# Risperidone

## OVERVIEW

### Introduction

Risperidone is an atypical antipsychotic that is used widely in the treatment of mania and schizophrenia. Risperidone therapy is associated with serum aminotransferase elevations and in rare instances has been linked to clinically apparent acute liver injury.

### Background

Risperidone (ris per' i done) is a benzisoxazole derivative which appears to act as a dopamine type 2 (D2) and serotonin (5-HT2) receptor antagonist. Risperidone is indicated for treatment of schizophrenia and as monotherapy or combination therapy for acute manic or mixed episodes of bipolar I disorder in adults. Risperidone is also used for management of irritability with autistic disorder in children and adolescents. Risperidone was approved for use in the United States in 1993 and it is still widely used. Risperidone is available as tablets of 0.25, 0.5, 1, 2, 3 and 4 mg generically and under the brand name of Risperdal. Oral solutions for pediatric use are available as are orally disintegrating tablets and formulations for parenteral administration. The typical initial dose in adults is 1 mg once or twice daily, with increase in dose to as high as 8 mg daily based upon indications, efficacy and tolerance. Common side effects include somnolence, fatigue, restlessness, dizziness, dry mouth, increased saliva, constipation, increased appetite and weight gain. Rare, but potentially severe adverse events include cerebrovascular events, tardive dyskinesia, neuroleptic malignant syndrome, orthostatic hypotension, suicidal ideation and behavior, seizures, diabetes and agranulocytosis.

### Hepatotoxicity

Liver test abnormalities may occur in up to 30% of patients on long term therapy with risperidone, usually arising within the first 8 weeks of treatment. The ALT elevations are usually mild, transient and may resolve even with continuation of medication. Instances of more marked ALT and alkaline phosphatase elevations, with or without symptoms and with or without jaundice, have also been reported. The onset of injury typically occurs within a few days of starting risperidone and resolves rapidly with stopping. Instances of acute liver injury with jaundice arising several months and even years after starting risperidone have also been reported. The pattern of serum enzyme elevations is typically cholestatic, but cases with hepatocellular and mixed patterns have also been described. Immunoallergic manifestations (rash, fever, eosinophilia) are rare; a case of autoimmune hepatitis apparently triggered by risperidone therapy has been published, but most cases do not have autoimmune features.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which risperidone causes serum ALT elevations is not known. Risperidone is extensively metabolized by the cytochrome P450 system (CYP 2D6) to its active metabolite. Some instances of liver injury may be due to nonalcoholic fatty liver disease caused by weight gain that occurs in at least one-quarter of treated patients and can be as much as 30 kg, generally during the first 1 to 2 years of therapy. In large series, however, the minor ALT elevations that occur on therapy have not correlated well with weight gain.

### Outcome and Management

The serum aminotransferase elevations that occur on risperidone therapy are usually self-limited and often do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome have been attributed to risperidone. A single case of autoimmune hepatitis due to risperidone has been published. There may be some cross reactivity to liver injury between risperidone and quetiapine, but usually not with clozapine and olanzapine.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Risperidone – Generic, Risperdal®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Risperidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Risperidone | 106266-06-2 | C23-H27-F-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of psychiatric agents mentions that at least 10 cases of liver injury have been ascribed to risperidone, some with steatosis and weight gain and others with acute clinical jaundice).
(1994). Risperidone for chronic schizophrenia. Med Lett Drugs Ther. (Brief review of efficacy and safety of risperidone shortly after its approval in the US; common side effects are asthenia, sedation and difficulty concentrating, orthostatic hypotension and weight gain; no mention of liver injury).
Fuller MA, Simon MR, Freedman L. (1996). Risperidone-associated hepatotoxicity. J Clin Psychopharmacol. (Two cases; 64 year old man developed jaundice 6 weeks after starting risperidone [bilirubin 16.1 mg/dL, ALT 297 U/L, Alk P 119 U/L], resolving upon stopping; 68 year old woman developed lethargy 1 year after starting risperidone [bilirubin 0.7 mg/dL, ALT 341 U/L, Alk P 174 U/L], resolving rapidly upon stopping).
Kumra S, Herion D, Jacobsen LK, Briguglia C, Grothe D. (1997). Case study: risperidone-induced hepatotoxicity in pediatric patients. J Am Acad Child Adolesc Psychiatry. (Retrospective review of 13 children on risperidone; 2 developed elevated ALT levels [108 and 144 U/L] with weight gain [16 and 5 kg] on long term risperidone [7 and 17 months], resolution on stopping risperidone even without much weight loss).
Geller WK, Zuiderwijk PB. (1998). Risperidone-induced hepatotoxicity?. J Am Acad Child Adolesc Psychiatry. (Letter disagreeing with comments of Kumra [1997], arguing against routine ALT monitoring for patients on risperidone).
Landau J, Martin A. (1998). Is liver function monitoring warranted during risperidone treatment?. J Am Acad Child Adolesc Psychiatry. (Overweight 13 year old girl found to have ALT elevations [164 U/L] 3 days after starting risperidone and steatohepatitis on biopsy; no values before starting therapy).
Benazzi F. (1998). Risperidone-induced hepatotoxicity. Pharmacopsychiatry. (25 year old woman treated with increasing doses of risperidone [to 6 mg/day] had 20 kg weight gain and fatigue; ALT rose from 13 [pre] to 277 U/L [month 4] without jaundice and fell to normal 1 month after stopping drug).
Phillips EJ, Liu BA, Knowles SR. (1998). Rapid onset of risperidone-induced hepatotoxicity. Ann Pharmacother. (81 year old man developed jaundice within 2 days of starting risperidone [bilirubin 3.6 mg/dL, ALT 101 U/L, Alk P 244 U/L], resolving 2 weeks after stopping).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, quetiapine +2.5, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg).
Whitworth AB, Liensberger D, Fleischhacker WW. (1999). Transient increase of liver enzymes induced by risperidone: two case reports. J Clin Psychopharmacol. (Two cases; 22 year old man had ALT elevation [106 U/L] 16 days after starting risperidone, which improved with lowering dose from 6 to 5 mg/day; 19 year old man had ALT elevation [43 U/L] which fell to normal despite continuing risperidone therapy).
Szigethy E, Wiznitzer M, Branicky LA, Maxwell K, Findling RL. (1999). Risperidone-induced hepatotoxicity in children and adolescents? A chart review study. J Child Adolesc Psychopharmacol. (Retrospective study of 38 children and adolescents on risperidone for ~15 months; only 1 had ALT elevation [46 U/L], degree of surveillance unclear; abstract only).
Conley RR, Conley RR. (2000). Risperidone side effects. J Clin Psychiatry. (Review of side effects of risperidone, but no mention of hepatotoxicity or ALT elevations).
Krebs S, Dormann H, Muth-Selbach U, Hahn EG, Brune K, Schneider HT. (2001). Risperidone-induced cholestatic hepatitis. Eur J Gastroenterol Hepatol. (37 year old man developed rises in ALT [140 U/L] and GGT [260 U/L] within days of starting risperidone, that continued on haloperidol [ALT 100 U/L] and olanzapine [ALT 160 U/L]; peak bilirubin 1.6 mg/dL; biopsy showed “cholestatic hepatitis”; tests fell to normal ~1 month after discontinuation).
Cordeiro Q, Elkis H. (2001). Pancreatitis and cholestatic hepatitis induced by risperidone. J Clin Psychopharmacol. (32 year old man developed abdominal pain and jaundice 1 week after starting risperidone [bilirubin 2.8 mg/dL, ALT 366 U/L, Alk P 367 U/L, amylase 1617 U/L], resolving rapidly with stopping).
Dumortier G, Cabaret W, Stamatiadis L, Saba G, Benadhira R, Rocamora JF, Aubriot-Delmas B, et al. (2002). Encephale. (Review of literature on liver injury due to atypical antipsychotics).
Mouradian-Stamatiadis L, Dumortier G, Januel D, Delmas BA, Cabaret W. (2002). Liver function tests during treatment with antipsychotic drugs: a case series of 23 patients. Prog Neuropsychopharmacol Biol Psychiatry. (23 hospitalized patients on atypical antipsychotics, 6 had ALT or AST elevations by day 14, ALT 48-158 U/L, 2 on risperidone, 2 on olanzapine and one on amisulpride; 1 on risperidone required discontinuation).
Haberfellner EM, Honsig T. (2003). Nonalcoholic steatohepatitis: a possible side effect of atypical antipsychotics. J Clin Psychiatry. (Three patients with weight gain [24-26 kg] had ALT elevations [47-91 U/L] on olanzapine or risperidone for ~4 years; ultrasound suggested fatty liver).
Prior TI, Baker GB. (2003). Interactions between the cytochrome P450 system and the second-generation antipsychotics. J Psychiatry Neurosci. (Review of the interactions of the atypical antipsychotics with the P450 system; clozapine is metabolized by CYP1A2 and 3A4 and possibly 2C9 and 2D6; risperidone by CYP2D6 and possibly 3A4; olanzapine by CYP1A2 and possibly 2D6; quetiapine and ziprasidone by CYP3A4).
Bender S, Grohmann R, Engel RR, Degner D, Dittmann-Balcar A, Ruther E. (2004). Severe adverse drug reactions in psychiatric inpatients treated with neuroleptics. Pharmacopsychiatry. (Severe adverse drug reactions among 35,293 inpatients; adverse events more common with atypicals [0.5-0.9%] than typical antipsychotic agents [0.02-0.2%], increased liver enzymes was the most common adverse reaction to olanzapine, 4th in frequency to clozapine, 6th to haloperidol, 7th to risperidone; no mention of hepatitis or acute liver failure).
Holtmann M, Kopf D, Mayer M, Bechtinger E, Schmidt MH. (2003). Risperidone-associated steatohepatitis and excessive weight-gain. Pharmacopsychiatry. (17 year old woman had significant weight gain [35 kg] and ALT elevations [108 U/L] on clozapine that worsened when switched to risperidone; ultrasound showed hypo-echogenicity suggestive of fatty liver; ALT levels decreased after stopping risperidone and a weight loss of 5 kg).
(2003). Choice of an antipsychotic. Med Lett Drugs Ther. (Risperidone is a second generation antipsychotic with the highest rate of galactorrhea, gynecomastia and sexual dysfunction; no mention of liver injury).
Aman MG, Arnold LE, McDougle CJ, Vitiello B, Scahill L, Davies M, McCracken JT, et al. (2005). Acute and long-term safety and tolerability of risperidone in children with autism. J Child Adolesc Psychopharmacol. (8 week trial of risperidone vs placebo in 101 children and adolescents; ALT levels rose to >2 times ULN in 2 risperidone- vs no placebo-recipients).
Llinares Tello F, Hernández Prats C, Bosacoma Ros N, Pérez Martínez E, Climent Grana E, Navarro Polo JN, Ordovás Baines JP. (2005). Acute cholestatic hepatitis probably associated with risperidone. Int J Psychiatry Med. (64 year old man developed rising serum enzymes between days 2 and 5 of risperidone treatment [bilirubin 0.5 mg/dL, ALT 186 U/L, Alk P 1326 U/L], values falling to near normal 2 weeks after stopping).
Radzik J, Grotthus B, Leszek J. (2005). Psychiatr Pol. (51 year old man developed jaundice after 4 years of risperidone therapy [bilirubin 2.5 mg/dL, AST 49 U/L, normal Alk P and GGT], possibly representing Gilbert syndrome and minor AST elevations from risperidone; unclear whether abnormalities resolved on stopping).
Pae CU, Lim HK, Kim TS, Kim JJ, Lee CU, Lee SJ, Lee C, et al. (2005). Naturalistic observation on the hepatic enzyme changes in patients treated with either risperidone or olanzapine alone. Int Clin Psychopharmacol. (Retrospective analysis found ALT elevations more common among 145 patients on olanzapine [25%] than 298 on risperidone [13%] and particularly >3 times ULN [7.6% vs 2.8%]; no instances of jaundice or hepatitis).
Esposito D, Brocvielle H, Becquemont L, Hardy P, Chouinard G, Corruble E. (2005). Risperidone-induced immunoallergic hepatitis. Am J Psychiatry. (28 year old man developed enzyme elevations 7 weeks and symptoms 8 weeks after starting risperidone [bilirubin normal, ALT 522 U/L], resolving within 3 weeks of stopping; smooth muscle antibody positive).
Legaz Huidobro ML, González Carro P, Pérez Roldán F, Soto Fernández S, de Pedro Esteban A, Cuesta Domínguez R. (2005). Gastroenterol Hepatol. (36 year old woman developed jaundice 10 days after starting risperidone [bilirubin rising from 15 to 29 mg/dL, ALT 818 U/L, Alk P 627 U/L, ANA of 1:320]; ALT continued to rise for 3 weeks [peak 1185 U/L] and prednisone was started with rapid response, but relapse [ALT 843 U/L, ANA 1:1280] when corticosteroids stopped, biopsy showing features of autoimmune hepatitis which was again controlled by prednisone and later with azathioprine alone).
Perlis RH, Baker RW, Zarate CA, Brown EB, Schuh LM, Jamal HH, Tohen M. (2006). Olanzapine versus risperidone in the treatment of manic or mixed States in bipolar I disorder: a randomized, double-blind trial. J Clin Psychiatry. (Trial of 3 weeks of olanzapine [n=165] vs risperidone [n=164] for bipolar illness; greater weight gain [16% vs 4%] and ALT elevations [mean increase 15.7 U/L vs 1 U/L] with olanzapine).
Rettenbacher MA, Baumgartner S, Eder-Ischia U, Edlinger M, Graziadei I, Hofer A, Huber R, et al. (2006). Association between antipsychotic-induced elevation of liver enzymes and weight gain: a prospective study. J Clin Psychopharmacol. (Prospective study of 67 patients started on atypical antipsychotics [10 on risperidone]; ALT elevations were more frequent in 14 patients who gained >7% of body weight than in 53 who did not [50% vs 19%] and mean changes in ALT, AST and GGT were greater; all were transient, asymptomatic and not associated with bilirubin elevations).
Wright TM, Vandenberg AM. (2007). Risperidone- and quetiapine-induced cholestasis. Ann Pharmacother. (30 year old man developed jaundice after 8 years of therapy with risperidone and lithium [bilirubin 4.7 mg/dL, ALT 99 U/L, Alk P 267 U/L], resolving with change of risperidone to ziprasidone, but recurring 3 weeks after starting quetiapine, after tolerating olanzapine).
Atasoy N, Erdogan A, Yalug I, Ozturk U, Konuk N, Atik L, Ustundag Y. (2007). A review of liver function tests during treatment with atypical antipsychotic drugs: a chart review study. Prog Neuropsychopharmacol Biol Psychiatry. (Retrospective analysis on 194 patients on atypical antipsychotics; ALT >3 times ULN occurred in 27%, often in first month; among 29 receiving risperidone, 28% had ALT elevations, but elevations were modest and none >3 times ULN).
Sikich L, Frazier JA, McClellan J, Findling RL, Vitiello B, Ritz L, Ambler D, et al. (2008). Double-blind comparison of first- and second-generation antipsychotics in early-onset schizophrenia and schizo-affective disorder: findings from the treatment of early-onset schizophrenia spectrum disorders (TEOSS) study. Am J Psychiatry. (Prospective trial of molindone [1st generation antipsychotic agent] vs olanzapine or risperidone [2nd generation agents] for schizophrenia in 199 youths found similar rates of efficacy [34-50%], but more weight gain [mean 6.1 kg] and ALT elevations with olanzapine).
Erdogan A, Atasoy N, Akkurt H, Ozturk D, Karaahmet E, Yalug I, Yalug K, et al. (2008). Risperidone and liver function tests in children and adolescents: a short-term prospective study. Prog Neuropsychopharmacol Biol Psychiatry. (Among 120 children and adolescents prospectively followed for one month on risperidone therapy, 52.5% had mild ALT elevations, but only 1 subject had ALT >3 times ULN [ALT 225 U/L, Alk P 641 U/L, bilirubin 0.4 mg/dL], resolving with discontinuation; no correlation with weight gain, which occurred in 57%).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; several antidepressants [duloxetine, sertaline, fluoxetine, amitryptilline], but none of the atypical antipsychotic agents were implicated).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; not with aripiprazole, ziprasidone, carbamazepine or lamotrigine).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, 0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects).
Paulzen M, Orfanos S, Gründer G. (2010). Remission of drug-induced hepatitis after switching from risperidone to paliperidone. Am J Psychiatry. (43 year old woman with schizophrenia developed jaundice on risperidone and clozapine therapy [bilirubin not given, ALT 75 U/L, Alk P 6 times ULN], improving on switching from risperidone to paliperidone and lowering clozapine dosage).
Lin CH, Kuo CC, Chou LS, Chen YH, Chen CC, Huang KH, Lane HY. (2010). A randomized, double-blind comparison of risperidone versus low-dose risperidone plus low-dose haloperidol in treating schizophrenia. J Clin Psychopharmacol. (Controlled trial of 6 weeks of risperidone alone vs lower dose risperidone and haloperidol in 88 patients with schizophrenia; no change in mean ALT or AST levels in either group and no mention of hepatotoxicity).
Erdogan A, Karaman MG, Ozdemir E, Yurteri N, Tufan AE, Kurcer MA. (2010). Six months of treatment with risperidone may be associated with nonsignificant abnormalities of liver function tests in children and adolescents: a longitudinal, observational study from Turkey. J Child Adolesc Psychopharmacol. (Among 102 children or adolescents [ages 2-18 years] treated with risperidone for more than 6 months, serum enzyme elevations occurred in 38%, but were usually transient and mild and isolated Alk P elevations only; only one child had ALT rise above twice normal [ALT 225 U/L, GGT 27 U/L, bilirubin 0.5 mg/dL], which resolved within one month of stopping; weight gain averaged 5.5 kg at 6 months).
Karaman MG, Erdoğan A, Tufan E, Yurteri N, Ozdemir E, Ankarali H. (2011). Liver function tests in children and adolescents receiving risperidone treatment for a year: a longitudinal, observational study from Turkey. Int J Psychiatry Clin Pract. (Among 100 children or adolescents treated with risperidone for more than 6 months, liver tests were abnormal in 21%, but none had symptoms and only one child had an ALT level above 3 times ULN, which resolved rapidly upon stopping).
Copur M, Erdogan A. (2011). Risperidone rechallenge for marked liver function test abnormalities in an autistic child. Recent Pat Endocr Metab Immune Drug Discov. (5 year old boy with autism was found to have elevations in serum enzymes during risperidone therapy, which resolved on stopping, but did not recur when risperidone was restarted).
Greil W, Häberle A, Schuhmann T, Grohmann R, Baumann P. (2013). Age and adverse drug reactions from psychopharmacological treatment: data from the AMSP drug surveillance programme in Switzerland. Swiss Med Wkly. (Among 39,728 patients treated with psychiatric medications in Swiss hospitals between 2001 and 2010 who were monitored in a drug surveillance program, rates of severe adverse events were similar in those above and below the age of 60 [1.6% vs 1.8%], although weight gain and ALT elevations were less frequent in the elderly [details not provided]).
López-Torres E, Süveges A. (2014). Peñas-LLedó EM, Doña A, Dorado P, LLerena A, Berecz R. Liver enzyme abnormalities during antipsychotic treatment: a case report of risperidone-associated hepatotoxicity. Drug Metabol Drug Interact. (19 year old man with schizophrenia developed fatigue and weight loss 3 weeks after starting risperidone [bilirubin normal, ALT 778, Alk P normal], resolving within 2 months of stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to risperidone or other atypical antipsychotic medications).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, five were attributed to atypical antipsychotics [3 quetiapine, 2 olanzapine], but none to risperidone).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Morlán-Coarasa MJ, Arias-Loste MT, Ortiz-García de la Foz V, Martínez-García O, Alonso-Martín C, Crespo J, Romero-Gómez M, et al. (2016). Incidence of non-alcoholic fatty liver disease and metabolic dysfunction in first episode schizophrenia and related psychotic disorders: a 3-year prospective randomized interventional study. Psychopharmacology (Berl). (Among 191 schizophrenic patients treated with an atypical antipsychotic agent for at least 3 years, surrogate markers for steatosis arose in 48 [25%], most of whom had a 7% increase in body weight [n=44: 92%], increase in triglycerides [54%], total cholesterol [52%], and waist circumference [68%]; changes in regard to fatty liver did not vary by specific antipsychotic agent [12 received risperidone]).
Saglam O, Bahsi R, Akkoca Y, Filik L. (2016). Risperidone-induced hepatotoxicity in a patient addicted to synthetic cannabinoid. Eur J Gastroenterol Hepatol. (31 year old man developed fatigue 3 months after starting risperidone to treat cannabinoid addiction [bilirubin 2.3 mg/dL, ALT 890 U/L, Alk P 736 U/L], resolving within 2 weeks of stopping).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 69 taking risperidone mean weight gain was 8.3 kg and ALT increase 2.7 U/L; increases in ALT associated most closely with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months).
Khorassani F, Sousonis F, Lopez LV. (2020). Risperidone- and paliperidone-induced hepatotoxicity: case report and review of literature. Am J Health Syst Pharm. (23 year old man with schizophrenia developed liver test abnormalities 13 days after starting risperidone [2 rising to 6 mg daily] with serum ALT rising from 25 to 469 U/L, falling when risperidone was stopped but rising again upon starting intramuscular paliperidone [234 mg], then gradually decreasing with a normal ALT 1 month later).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Risperidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Risperidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Risperidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Risperidone)